# Clofarabine

## OVERVIEW

### Introduction

Clofarabine is a purine analogue and antineoplastic agent used in the therapy of acute lymphoblastic leukemia (ALL) in children. Clofarabine is associated with frequent transient serum enzyme elevations during therapy, but they are usually asymptomatic and transient and it has only rarely been implicated in causing clinically apparent acute liver injury with jaundice.

### Background

Clofarabine (kloe far' a been) is a purine analogue that is used in the treatment of acute lymphoblastic leukemia (ALL) in children and is used off-label in other forms of leukemia and myelodysplastic syndromes. Clofarabine is a fluorinated arabinosyladenine derivative that is converted intracellularly to the active triphosphate, which is believed to compete with adenine triphosphate for uptake and use by DNA polymerase leading to inhibition of DNA synthesis. Clofarabine was found to have activity against acute leukemia and was approved for use as an antineoplastic agent in the United States in 2004. Current indications are therapy of acute lymphoblastic leukemia in children after failure of prior therapies. Clofarabine is available as a powder for injection generically and under the trade name Clolar. The typical pediatric dose for ALL is 52 mg/m^2^ intravenously once daily for 5 days, with repeat courses every 2 to 6 weeks. Common side effects include bone marrow suppression, leucopenia, infections, fever, nausea, vomiting, anorexia, diarrhea, headache, fatigue, mucositis and skin rash. Clofarabine has been associated with rare instances of capillary leak syndrome marked by hypotension, tachypnea, edema, and progressive pulmonary and renal failure which is frequently fatal. Corticosteroids are typically given with clofarabine to help prevent this syndrome.

### Hepatotoxicity

In clinical trials, serum enzymes elevations occurred in up to 75% of patients treated with clofarabine as monotherapy for refractory or relapsed acute leukemia. These elevations usually arose within 5 to 10 days of starting therapy and were generally transient and asymptomatic. The elevations rarely required dose adjustment or delay in therapy. Cases of clinically apparent liver injury due to clofarabine have been reported to occur, but few details were available and most patients were receiving other cancer chemotherapeutic agents. A single case report of toxic epidermal necrosis and fulminant hepatic failure in a child with ALL receiving clofarabine has been published. In high doses, clofarabine has been associated with very high rates of serum enzyme elevations and hyperbilirubinemia that are dose limiting. Instances of capillary leak syndrome and possibly sinusoidal obstruction syndrome have also been reported.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Hepatotoxicity from clofarabine is likely due to direct toxicity, as is typical for other purine analogues.

### Outcome and Management

The severity of the liver injury linked to clofarabine therapy is generally self-limited and mild, and resolves with stopping therapy. However, instances of hepatic failure have been reported in patients receiving cancer chemotherapeutic regimens that include clofarabine. For these reasons, the product label recommends prospective monitoring of liver tests and immediate discontinuation of clofarabine for ALT elevations above 5 times ULN or the appearance of jaundice or symptoms of hepatitis. Liver injury is most frequent with higher doses. There is little evidence of cross sensitivity to liver injury among the various antineoplastic or antiviral purine analogues.

Drug Class: Antineoplastic Agents, Antimetabolites

Other Drugs in the Subclass, Purine Analogues: Azathioprine, Cladribine, Fludarabine, Mercaptopurine, Nelarabine, Pentostatin, Thioguanine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clofarabine – Clolar®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Clofarabine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clofarabine | 123318-82-1 | C10-H11-Cl-F-N5-O3 | Clofarabine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 October 2017

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 discusses the purine analogues pentostatin, cladribine and fludarabine, but not clofarabine or nelarabine).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of hepatotoxicity of anticancer agents does not discuss clofarabine).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Purine analogs. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1701-5. (Textbook of pharmacology and therapeutics).
Kantarjian H, Gandhi V, Cortes J, Verstovsek S, Du M, Garcia-Manero G, Giles F, et al. Phase 2 clinical and pharmacologic study of clofarabine in patients with refractory or relapsed acute leukemia. Blood 2003; 102: 2379-86. (Among 62 adults with various forms of refractory leukemia treated with clofarabine [52 mg/m^2^ daily for 5 days every 2-6 weeks], ALT elevations occurred in 74% and hyperbilirubinemia in 50%, but there were no liver related serious adverse events). 12791647
Jeha S, Gandhi V, Chan KW, McDonald L, Ramirez I, Madden R, Rytting M, Brandt M, Keating M, Plunkett W, Kantarjian H. Clofarabine, a novel nucleoside analog, is active in pediatric patients with advanced leukemia. Blood 2004; 103: 784-9. (Dose finding study of clofarabine in 25 patients with advanced leukemia; the dose limiting toxicities were skin rash and hepatotoxicity, but liver injury resolved in all patients; few details given). 14551141
Pui CH, Jeha S, Kirkpatrick P. Clofarabine. Nat Rev Drug Discov 2005; 4: 369-70. (Brief review of structure, mechanism of action, efficacy and clinical indications for clofarabine shortly after its approval for use by the FDA). 15902772
Curran MP, Perry CM. Clofarabine: in pediatric patients with acute lymphoblastic leukemia. Paediatr Drugs 2005; 7: 259-64. (Review of the structure, mechanism of action, pharmacokinetics, efficacy and safety of clofarabine in children with ALL; mentions that transient elevations in serum enzymes can occur and that four cases of capillary leak syndrome due to clofarabine have been reported). 16117562
Faderl S, Gandhi V, O'Brien S, Bonate P, Cortes J, Estey E, Beran M, et al. Results of a phase 1-2 study of clofarabine in combination with cytarabine (ara-C) in relapsed and refractory acute leukemias. Blood 2005; 105: 940-7. (Among 32 adults given clofarabine and cytarabine for previously treated acute leukemia, hyperbilirubinemia occurred in 67-80% and ALT elevations in 42-65%, generally between day 7 and 28 of the first course, but resolving in all). 15486072
Jeha S, Gaynon PS, Razzouk BI, Franklin J, Kadota R, Shen V, Luchtman-Jones L, et al. Phase II study of clofarabine in pediatric patients with refractory or relapsed acute lymphoblastic leukemia. J Clin Oncol 2006; 24: 1917-23. (Among 61 children with previously treated ALL who received several courses of clofarabine, ALT elevations above 5 times ULN occurred in 43%, usually peaking by day 7 of therapy and resolving by day 16). 16622268
Gandhi V, Plunkett W. Clofarabine and nelarabine: two new purine nucleoside analogs. Curr Opin Oncol 2006; 18: 584-90. (Review of clofarabine and nelarabine, both of which were recently approved for use in ALL and T cell leukemia or lymphoma, dose limiting toxicities being hepatic for clofarabine, neurologic for nelarabine). 16988579
Johnston DL, Mandel KM. Fatal skin and liver toxicity in a patient treated with clofarabine. Pediatr Blood Cancer 2008; 50: 1082. (9 year old girl with relapsed ALL developed liver enzyme elevations 2 days after starting clofarabine, followed by facial edema, rash, desquamation, jaundice and death from liver failure within 2 weeks of starting chemotherapy; few details given). 17957757
Locatelli F, Testi AM, Bernardo ME, Rizzari C, Bertaina AP, Pession A, Giraldi E, et al. Clofarabine, cyclophosphamide and etoposide as single-course re-induction therapy for children with refractory/multiple relapsed acute lymphoblastic leukaemia. Br J Haematol 2009; 147: 371-8. (Among 25 children with relapsed ALL treated with a single course of clofarabine, cyclophosphamde and etoposide, liver toxicity was frequent [64%], but invariably mild and asymptomatic, arising within 3-10 days of starting and resolving within 10 days). 19747360
Jeha S, Razzouk B, Rytting M, Rheingold S, Albano E, Kadota R, Luchtman-Jones L, et al. Phase II study of clofarabine in pediatric patients with refractory or relapsed acute myeloid leukemia. J Clin Oncol 2009; 27: 4392-7. (Among 42 children with AML treated with clofarabine, 43% developed ALT elevations above 5 times ULN and 12% hyperbilirubinemia, but none developed clinically apparent liver injury or sinusoidal obstruction syndrome). 19652076
Baytan B, Ozdemir O, Gunes AM, Döz O. Clofarabine-induced capillary leak syndrome in a child with refractory acute lymphoblastic leukemia. J Pediatr Hematol Oncol 2010; 32: 144-6. (12 year old girl with refractory ALL developed hypotension on day 4 of a second course of clofarabine, etoposide and cyclophosphamide with subsequent edema, renal and pulmonary failure and progressive capillary leak syndrome resulting in death). 20057324
Advani AS, Gundacker HM, Sala-Torra O, Radich JP, Lai R, Slovak ML, Lancet JE, et al. Southwest Oncology Group Study S0530: a phase 2 trial of clofarabine and cytarabine for relapsed or refractory acute lymphocytic leukaemia. Br J Haematol 2010; 151: 430-4. (Among 37 adults with refractory ALL treated with clofarabine and cytarabine, only 17% achieved a complete response and toxicities were common; no mention of hepatotoxicity or ALT elevations). 21113977
Hijiya N, Thomson B, Isakoff MS, Silverman LB, Steinherz PG, Borowitz MJ, Kadota R, et al. Phase 2 trial of clofarabine in combination with etoposide and cyclophosphamide in pediatric patients with refractory or relapsed acute lymphoblastic leukemia. Blood 2011; 118: 6043-9. (Pilot study of combination of clofarabine [40 mg/kg/day] with etoposide and cyclophosphamide in children with ALL who had failed previous therapy found unacceptable toxicity, 4 of first 8 patients with severe hepatotoxicity suggestive of sinusoidal obstruction syndrome, not seen with lower doses). 21967976
Faderl S, Garcia-Manero G, Jabbour E, Ravandi F, Borthakur G, Estrov Z, Gandhi V, et al. A randomized study of 2 dose levels of intravenous clofarabine in the treatment of patients with higher-risk myelodysplastic syndrome. Cancer 2012; 118: 722-8. (Pilot study of two doses of clofarabine in 58 adults with myelodysplastic syndromes found higher rates of bilirubin and ALT elevations in patients treated with the higher dose). 21751197
Advani AS, McDonough S, Coutre S, Wood B, Radich J, Mims M, O'Donnell M, Et al. SWOG S0910: a phase 2 trial of clofarabine/cytarabine/epratuzumab for elapsed/refractory acute lymphocytic leukaemia. Br J Haematol 2014; 165: 504-9. (Among 35 adults with refractory ALL treated with clofarabine, cytarabine and epratuzumab [anti-CD22], the response rate was 52%, but adverse events were common, including ALT elevations above 5 times ULN in 11 patients [31%], one of whom had "hepatic failure", but there were no liver related deaths ). 24579885
Martínez-Cuadrón D, Montesinos P, Oriol A, Salamero O, Vidriales B, Bergua J, Herrera P, et al. Phase II trial to assess the safety and efficacy of clofarabine in combination with low-dose cytarabine in elderly patients with acute myeloid leukemia. Ann Hematol 2014; 93: 43-6. (Among 11 elderly adults with AML treated with clofarabine with low doses of cytarabine, the response rate was 27%, but the mortality rate rose to 73% at 8 weeks and one death was attributed to hepatic and renal failure). 24081577
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases [5%] were attributed to antineoplastic agents, but none to clofarabine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Clofarabine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Clofarabine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Clofarabine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Clofarabine)